# Enzyme Replacement Therapy

## OVERVIEW

### Introduction

Enzyme replacement therapy refers to treatment of congenital enzyme deficiencies using purified human, animal or recombinant enzyme preparations. The enzymes are given parenterally, usually by intravenous infusion. The diseases treated are generally rare genetic disorders which lead to severe disability and premature death.

### Background

Enzyme replacement therapy is typically used to replace a missing or deficient enzyme in a person with an inherited enzyme deficiency syndrome. The missing enzyme is replaced by infusions of an enzyme that is purified from human or animal tissue or blood or produced by novel recombinant techniques. Typically, the enzyme is modified to allow for a longer half-life, more potent activity, resistance to degradation or targeting to a specific organ, tissue or cell type. The first successful enzyme replacement therapies were for alpha-1-antitrypsin (A1AT) deficiency using plasma derived purified human A1AT. A1AT deficiency is associated with early onset emphysema attributed to the lack of leukocyte elastase inhibitor which leads to progressive pulmonary damage. Small prospective studies suggested a benefit from augmentation therapy, raising the levels of A1AT in serum by infusing the enzyme purified from human serum. This therapy was eventually shown to be beneficial, particularly in patients with early or intermediate pulmonary dysfunction and was quite safe, without the occurrence of viral hepatitis, despite being prepared from human plasma.

A second form of successful enzyme replacement therapy was established for Gaucher disease, an inherited deficiency of lysosomal acid β-glucocerebrosidase that leads to accumulation of the substrate (glucocerebroside and its other breakdown products such as ceramide) in lysosomes. The major tissues affected are liver, spleen and bone. The glucocerebrosidase was initially prepared from placental tissue and was modified to allow its specific uptake by macrophages and delivery into lysosomes. Subsequently, recombinant forms of glucocerebrosidase have been developed and now constitute the standard of care for type 1 Gaucher disease.

Subsequently, similar or related approaches have been taken to treat other enzyme deficiency syndromes such as adenosine deaminase deficiency, lysosomal acid lipase deficiency, Fabry disease, Pompe disease, Hurler and Hunter syndrome and several of the rarer forms of mucopolysaccharidoses. A list of enzymes approved for use in enzyme replacement therapy in the United States, the year of first approval, the generic and brand names of the product and the disease for which they are used are given in the Table.

Natural purified and recombinant enzymes are generally well tolerated with minimal systemic adverse reactions. The usual major reactions to enzyme replacement therapy are local infusion reactions and hypersensitivity reactions. Hypersensitivity can be a difficult problem, not just in causing allergic symptoms but also in causing inactivity of the enzyme by cross reacting antibodies. Hypersensitivity reactions are generally more common and more severe in patients with total absence of the enzyme, rather than a deficiency or minor amino acid mutation that inactivates the protein. Hypersensitivity reactions can be severe with rash, fever, hypotension, angioneurotic edema, bronchospasm, anaphylaxis and cardio-pulmonary collapse. Most reactions, however, are mild and transient and may be prevented by premedication with antihistamines, antipyretics or corticosteroids.

Enzyme Replacement Therapies

Generic Name | Brand Name | Enzyme | Year | Disease
Alpha1-Proteinase inhibitor | Prolastin-C Glassia | Alpha1-Antitrypsin | 2009 2010 | A1AT Deficiency
Alglucerase alfa | Ceredase* | β-Glucocerebrosidase | 1991 | Gaucher
Imiglucerase | Cerezyme | β-Glucocerebrosidase | 1995 | Gaucher
Taliglucerase alfa | Elelyso | β-Glucocerebrosidase | 2012 | Gaucher
Velaglucerase alfa | VPRIV | β-Glucocerebrosidase | 2010 | Gaucher
Pegademase | Adagen | Adenosine Deaminase | 2000 | ADA Deficiency
Agalsidase beta | Fabrazyme | Alpha-Galactosidase A | 2003 | Fabry
Alglucosidase alfa | Lumizyme | Acid alpha-Glucosidase | 2010 | Pompe
Laronidase | Aldurazyme | α-L-Iduronidase | 2003 | Hurler, MPS I
Idursulfase | Elaprase | Iduronate-2-Sulfatase | 2006 | Hunter, MPS II
Elosulfase alfa | Vimizim | N-Acetylgalactosamine-6 Sulfatase | 2014 | Morquio Snydrome A, MPS IVA
Galsulfase | Naglazyme | N-Acetylgalactosamine-4 Sulfatase | 2005 | Maroteaux-Lamy, MPS VI
Sebelipase alfa | Kanuma | Lysosomal Acid Lipase | 2015 | Wolman, LAL Deficiency

* Withdrawn from market.

MPS=Mucopolysaccharidosis.

### Hepatotoxicity

Enzyme replacement therapies generally cause little evidence for liver injury. Minor, transient elevations in serum enzymes occur with some agents, but none of the current enzyme replacement therapies have been associated with severe liver test abnormalities or clinically apparent liver injury with jaundice. None of the replacement therapies have been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. Indeed, many enzyme replacement therapies can lead to an improvement in liver injury associated with the underlying condition, and improvement in hepatic function or serum enzyme elevations has been used as a surrogate endpoint for efficacy of some treatments (such as lysosomal acid lipase deficiency).

Likelihood score for Enzyme Replacement Therapies: E (unlikely causes of liver injury).

### Mechanism of Injury

Some enzyme replacement therapies are recombinant proteins that share a high degree of homology with the human enzyme. Proteins are metabolized in multiple organs and tissues into polypeptides and amino acids. There is no reason for these proteins to cause liver disease other than by a hypersensitivity reaction or possibly by their direct enzymatic reactivity acting upon the liver.

### Outcome and Management

Serum enzyme elevations that occur on enzyme replacement therapies are usually self-limited and mild and generally do not require dose modification or discontinuation of therapy. Persistent or prominent elevations should lead to evaluation for other forms of liver disease. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome due to sebelipase have been reported.

Drug Class: Genetic Disorder Agents; Gaucher Disease Agents; Sebelipase alfa

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Agalsidase beta – Fabrazyme®

Alglucosidase alfa – Lumizyme®

Imiglucerase – Cerezyme®

Pegademase – Adagen®

DRUG CLASS

Enzyme Replacement Therapy

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Enzyme+Replacement+Therapy)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Various | Not Applicable | Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2016

### Overview

Baldo BA. Enzymes approved for human therapy: indications, mechanisms and adverse effects. BioDrugs 2015; 29: 31-55. (Review of enzymes that are approved for use in the US including those used for enzyme replacement therapy [for Gaucher, Fabry, Pompe, and several MPS] as well as those for specific diseases [dornase for cystic fibrosis, alteplase for myocardial infarction and stroke, L-asparaginase for cancer, and pegloticase for gout]; no mention of ALT elevations or hepatotoxicity except for L-asparaginase). 25648140

### Gaucher Disease

Elstein D, Zimran A. Review of the safety and efficacy of imiglucerase treatment of Gaucher disease. Biologics 2009; 3: 407-17. (Review of the pathogenesis and clinical features of Gaucher disease, types 1, 2 and 3, as well as the development of enzyme replacement therapy and long term efficacy and safety of imiglucerase, a human recombinant form of glucocerebrosidase that was given intravenously every 2 weeks and largely replaced the placental tissue derived product [alglucerase] which was given 3 times weekly). 19774208
Velaglucerase (Vpriv) for Gaucher's disease. Med Lett Drugs Ther 2010; 52 (1337): 36. (Concise review of the mechanism of action, efficacy and cost of velaglucerase, shortly after this second recombinant form of glucocerebrosidase was approved as therapy of type 1 Gaucher disease; no discussion of adverse events). 20508578

### Lysosomal Acid Lipase Deficiency (Cholesterol Ester Storage Disease, Wolman Disease)

Balwani M, Breen C, Enns GM, Deegan PB, Honzík T, Jones S, Kane JP, et al. Clinical effect and safety profile of recombinant human lysosomal acid lipase in patients with cholesteryl ester storage disease. Hepatology 2013; 58: 950-7. (Phase 1 and 2 studies of recombinant lysosomal acid lipase [sebelipase alfa] in 9 adults with cholesterol ester storage disease found the infusions to be well tolerated and to result in decreases in serum cholesterol, ALT and AST levels, with relapse upon stopping and sustained improvements with extended therapy). 23348766
Grabowski G. Therapy for lysosomal acid lipase deficiency: replacing a missing link. Hepatology 2013; 58: 850-2. (Review of the role of lysosomal acid lipase in cholesterol metabolism, the consequences of its deficiency and the possible role of recombinant enzyme replacement therapy). 23471861
Valayannopoulos V, Malinova V, Honzík T, Balwani M, Breen C, Deegan PB, Enns GM, et al. Sebelipase alfa over 52 weeks reduces serum transaminases, liver volume and improves serum lipids in patients with lysosomal acid lipase deficiency. J Hepatol 2014; 61: 1135-42. (Among 8 adults with cholesterol ester storage disease treated in an open-label extension study with infusions of sebelipase every other week for at least one year, serum ALT and AST levels became and remained normal and liver volume and fat content decreased; side effects included 2 hypersensitivity reactions in patient, who later tolerated restarting treatment; no mention of liver injury or serum enzyme elevations). 24993530
Burton BK, Balwani M, Feillet F, Barić I, Burrow TA, Camarena Grande C, Coker M, et al. A phase 3 trial of sebelipase alfa in lysosomal acid lipase deficiency. N Engl J Med 2015; 373: 1010-20. (Among 66 patients [ages 4 to 54 years] with lysosomal acid lipase deficiency [38 with cirrhosis] treated with infusions of sebelipase or placebo every 2 weeks for 20 weeks, serum ALT, AST and cholesterol levels and hepatic volume and fat content improved more with active enzyme therapy than placebo; one patient had a mild hypersensitivity reaction, but was able to continue therapy and there were no hepatic adverse effects mentioned). 26352813
Rader DJ. Lysosomal acid lipase deficiency--a new therapy for a genetic lipid disease. N Engl J Med 2015; 373: 1071-3. (Editorial in response to Burton [2015] discusses the etiology, pathogenesis and long term consequences of lysosomal acid lipase deficiency and the rationale for a glycosylated, mannose-terminated recombinant enzyme that targets hepatocytes via the mannose-6-phosphate receptor). 26352819

### Alpha-1-Antitrypsin (A1AT) Deficiency

Seersholm N, Wencker M, Banik N, Viskum K, Dirksen A, Kok-Jensen A, Konietzko N. Does alpha1-antitrypsin augmentation therapy slow the annual decline in FEV1 in patients with severe hereditary alpha1-antitrypsin deficiency? Wissenschaftliche Arbeitsgemeinschaft zur Therapie von Lungenerkrankungen (WATL) alpha1-AT study group. Eur Respir J 1997; 10: 2260-3. (Analysis of changes in lung function [FEV1] in 198 German patients with A1AT deficiency receiving weekly infusions of A1AT [purified from human plasma] compared to 97 Danish patients who were not being treated, found less decrease in FEV1 in treated subjects; no mention of adverse events). 9387950
Wencker M, Banik N, Buhl R, Seidel R, Konietzko N. Long-term treatment of alpha1-antitrypsin deficiency-related pulmonary emphysema with human alpha1-antitrypsin. Wissenschaftliche Arbeitsgemeinschaft zur Therapie von Lungenerkrankungen (WATL)-alpha1-AT-study group. Eur Respir J 1998; 11: 428-33. (Among 443 patients with A1AT deficiency treated with weekly infusions of human A1AT [plasma derived], 65 had adverse events, but these were largely infusion reactions which were repeated and severe in 3 [fever, chills]; no patient developed viral hepatitis, but there was no mention of ALT levels). 9551749
Survival and FEV1 decline in individuals with severe deficiency of alpha1-antitrypsin. The Alpha-1-Antitrypsin Deficiency Registry Study Group. Am J Respir Crit Care Med 1998; 158: 49-59. (Among 1048 patients with A1AT deficiency followed in a natural history study, showed a decreased mortality in those receiving A1AT infusions and those with intermediate baseline declines in FEV1 had less decline if they were receiving A1AT infusions; no mention of adverse events). 9655706
Dirksen A, Dijkman JH, Madsen F, Stoel B, Hutchison DC, Ulrik CS, Skovgaard LT, et al. A randomized clinical trial of alpha (1)-antitrypsin augmentation therapy. Am J Respir Crit Care Med 1999; 160: 1468-72. (Among 56 patients with A1AT deficiency treated with A1AT or placebo infusions every 4 weeks for 3 years, the loss of lung tissue as measured by CT was less with the enzyme infusions while changes in FEV1 were not; “no adverse effects of treatment or placebo were observed”). 10556107
Campos MA, Lascano J. α1 Antitrypsin deficiency: current best practice in testing and augmentation therapy. Ther Adv Respir Dis 2014; 8: 150-61. (Review of the genetics, clinical features, diagnosis and management of A1AT deficiency mentions that adverse reactions to A1AT infusion therapy are rare, usually transitory and may include headache, nausea and dizziness; no mention of ALT elevations or hepatotoxicity). 25013223

### Adenosine Deaminase (ADA) Deficiency

Booth C, Gaspar HB. Pegademase bovine (PEG-ADA) for the treatment of infants and children with severe combined immunodeficiency (SCID). Biologics 2009; 3: 349-58. (Review of efficacy and safety of pegademase mentions that more than 150 patients have been treated with this enzyme which allows for disease stabilization and “no toxic or hypersensitivity reactions have been reported” with its use, the main side effect being development of antibodies to bovine ADA in up to 80% of recipients, but is rarely clinically significant; no mention of ALT elevations or hepatotoxicity). 19707420

### Pompe Disease

Broomfield A, Fletcher J, Davison J, Finnegan N, Fenton M, Chikermane A, Beesley C, et al. Response of 33 UK patients with infantile-onset Pompe disease to enzyme replacement therapy. J Inherit Metab Dis 2016; 39: 261-71. (Among 33 children with Pompe disease [lysosomal acid maltase deficiency] who were treated with every other week infusions of recombinant alglucosidase for 0.5 to 13.5 years, 13 [40%] died and 13 [40%] survived ventilation-free, factors associated with poor outcome being older age at starting therapy, cross reactive antibodies and failure to thrive; adverse events included severe infusion reactions [25%]; no mention of ALT elevations or hepatotoxicity). 26497565
Stepien KM, Hendriksz CJ, Roberts M, Sharma R. Observational clinical study of 22 adult-onset Pompe disease patients undergoing enzyme replacement therapy over 5years. Mol Genet Metab 2016 Feb 4. [Epub ahead of print] (Among 22 adults with Pompe disease treated with alglucosidase [20 mg/kg every other week] for at least 5 years, there was continued increase in ventilation requirement and wheel chair dependence; therapy was “well tolerated” and there were no deaths from liver disease or mention of ALT elevations or hepatotoxicity). 26873529

### Fabry Disease

Goláň L, Goker-Alpan O, Holida M, Kantola I, Klopotowski M, Kuusisto J, Linhart A, et al. Evaluation of the efficacy and safety of three dosing regimens of agalsidase alfa enzyme replacement therapy in adults with Fabry disease. Drug Des Devel Ther 2015; 9: 3435-44. (Among 44 adults with Fabry disease treated with weekly infusions of agalsidase, 25% had infusions reactions, but none were severe; no mention of ALT elevations or hepatotoxicity). 26185417
Schiffmann R, Pastores GM, Lien YH, Castaneda V, Chang P, Martin R, Wijatyk A. Agalsidase alfa in pediatric patients with Fabry disease: a 6.5-year open-label follow-up study. Orphanet J Rare Dis 2014; 9: 169. (Among 11 children with Fabry disease treated for up to 6 years with agalsidase, 6 had infusion reactions but all were able to continue therapy; there were no drug related serious adverse events and no mention of ALT elevations or hepatotoxicity). 25425121
Wilcox WR, Banikazemi M, Guffon N, Waldek S, Lee P, Linthorst GE, Desnick RJ, et al.; International Fabry Disease Study Group. Long-term safety and efficacy of enzyme replacement therapy for Fabry disease. Am J Hum Genet 2004; 75: 65-74. (Among 58 patients with Fabry disease treated with agalsidase for 30 to 36 months, 8 had serious infusion reactions; no mention of ALT elevations or hepatotoxicity). 15154115

### Mucopolysaccharidoses, types I (Hurler), II (Hunter), IVA (Morquio A), and VI (Maroteaux-Lamy).

Clarke LA, Wraith JE, Beck M, Kolodny EH, Pastores GM, Muenzer J, Rapoport DM, et al. Long-term efficacy and safety of laronidase in the treatment of mucopolysaccharidosis I. Pediatrics 2009; 123: 229-40. (Among 40 patients with MPS-1 treated with laronidase in a 3.5 year extension study, infusion reactions occurred in 53% which was associated with anaphylaxis in one patient; hepatomegaly decreased with treatment and there was no mention of ALT elevations or liver related adverse events). 19117887
Muenzer J, Beck M, Eng CM, Giugliani R, Harmatz P, Martin R, Ramaswami U, et al. Long-term, open-labeled extension study of idursulfase in the treatment of Hunter syndrome. Genet Med 2011; 13: 95-101. (Among 94 patients with Hunter syndrome treated long term with weekly, intravenous idursulfase infusions, improvements in FEV1, walking distance and mean liver and spleen volumes were sustained, and while 53% of children had infusion related adverse events, these decreased with time and were not dose limiting; no mention of ALT elevations or hepatotoxicity). 21150784
Horovitz DD, Magalhães TS, Acosta A, Ribeiro EM, Giuliani LR, Palhares DB, Kim CA, et al. Enzyme replacement therapy with galsulfase in 34 children younger than five years of age with MPS VI. Mol Genet Metab 2013; 109: 62-9. (Among 34 Brazilian children with MPS VI started on weekly infusions of galsulfase before the age of 5 years, there were no severe infusion reactions or adverse events considered treatment related; no mention of ALT elevations or hepatotoxicity). 23535281
Hendriksz CJ, Giugliani R, Harmatz P, Lampe C, Martins AM, Pastores GM, Steiner RD, et al.; CSP Study Group. Design, baseline characteristics, and early findings of the MPS VI (mucopolysaccharidosis VI) Clinical Surveillance Program (CSP). J Inherit Metab Dis 2013; 36: 373-84. (Among 123 patients with MPS VI [ages 1 to 59 years] receiving enzyme replacement therapy, height and weight increased and liver and spleen size decreased; infusion reactions were the most common adverse event and some required corticosteroids or antihistamines; no mention of ALT elevations or hepatotoxicity and no deaths were due to liver disease). 22127392
Giugliani R, Hwu WL, Tylki-Szymanska A, Whiteman DA, Pano A. A multicenter, open-label study evaluating safety and clinical outcomes in children (1.4-7.5 years) with Hunter syndrome receiving idursulfase enzyme replacement therapy. Genet Med 2014; 16: 435-41. (Among 28 boys with Hunter syndrome treated with idursulfase infusions, liver volume decreased by 17% and spleen volume by 21% and, while 17 children had infusion reactions [57%], there were “no clinically important changes in laboratory parameters”). 24202085
Hendriksz CJ, Burton B, Fleming TR, Harmatz P, Hughes D, Jones SA, Lin SP, et al. Efficacy and safety of enzyme replacement therapy with BMN 110 (elosulfase alfa) for Morquio A syndrome (mucopolysaccharidosis IVA): a phase 3 randomised placebo-controlled study. J Inherit Metab Dis 2014; 37: 979-90. (Among 176 patients with Morquio A syndrome [ages 5 to 57] treated with placebo or elosulfase weekly or every other week, modest improvements occurred with weekly elosulfase infusions; infusion reactions were common but did not necessitate permanent discontinuation; no mention of ALT elevations or hepatotoxicity). 24810369
Giugliani R, Lampe C, Guffon N, Ketteridge D, Leão-Teles E, Wraith JE, Jones SA, et al. Natural history and galsulfase treatment in mucopolysaccharidosis VI (MPS VI, Maroteaux-Lamy syndrome)--10-year follow-up of patients who previously participated in an MPS VI Survey Study. Am J Med Genet A 2014; 164A: 1953-64. (Among 59 patients enrolled in a multinational survey of MPS VI who had long term follow up [55 receiving galsulfase], there was modest improvements in walking distance and pulmonary function; data on side effects were not collected). 24764221
Burton BK, Berger KI, Lewis GD, Tarnopolsky M, Treadwell M, Mitchell JJ, Muschol N, et al. Safety and physiological effects of two different doses of elosulfase alfa in patients with Morquio A syndrome: A randomized, double-blind, pilot study. Am J Med Genet A 2015; 167A: 2272-81. (Among 25 patients with Morquio A syndrome treated with elosulfase [2 or 4 mg/kg weekly] exercise capacity improved slightly with treatment, infusion reactions were frequent, but did not require permanent discontinuation, and there were “no clinically meaningful changes in …clinical chemistry ...results”). 26069231

## OTHER REFERENCE LINKS

1. Recent References on Enzyme Replacement Therapy: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Enzyme%20Replacement%20Therapy+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Enzyme Replacement Therapy: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Enzyme%20Replacement%20Therapy)